# Entacapone

## OVERVIEW

### Introduction

Entacapone is a catechol-O-methyltransferase inhibitor used in the therapy of Parkinson disease as adjunctive therapy in combination with levodopa and carbidopa. Entacapone has been associated with a low rate of serum enzyme elevations during treatment, but has yet to be implicated in cases of clinically apparent acute liver injury with jaundice.

### Background

Entacapone (en tak' a pone) is a specific inhibitor of cathechol-O-methyltransferase (COMT) which is a major enzyme in the pathway of levodopa metabolism. As a result, entacapone slows the metabolism of levodopa, causing an increase in its bioavailability and duration of action. Entacapone inhibits COMT activity only peripherally, unlike tolcapone which acts both peripherally and centrally. Entacapone was approved for use in the United States in 2003, the second COMT inhibitor approved for use in the therapy of symptomatic Parkinson disease as an adjunct to levodopa/carbidopa therapy in patients with motor complications. Entacapone is available in tablets of 200 mg generically and under the brand name of Comtan. It is also available in several fixed dose combinations with carbidopa and levodopa generically and under the brand name Stalevo. Entacapone is typically initiated in doses of 200 mg with each dose of levodopa/carbidopa to a maximum of 1600 mg daily. Common side effects include somnolence, dizziness, confusion, dyskinesia, vivid dreams, hallucinations, depression, fatigue, headache, diarrhea and gastrointestinal upset, side effects that are largely due to enhancement of the dopaminergic effects of levodopa. Uncommon, but potentially severe adverse events include hypotension, hallucinations, acute psychosis, impulsive behaviors, excessive daytime sleepiness, diarrhea and colitis and severe dyskinesia.

### Hepatotoxicity

Entacapone therapy has been associated with serum aminotransferase elevations (above 3 times the upper limit of normal) in only 0.3% to 0.5% of patients, which is similar or minimally higher than the rate in subjects receiving placebo. The elevations were usually transient and asymptomatic and rarely required dose adjustment. In preliminary clinical trials, there were no reports of clinically apparent serious liver injury with jaundice. Subsequently, isolated instances of hepatotoxicity have been reported to the sponsor, injury arising 2 to 6 weeks after starting entacapone with mild jaundice and cholestatic pattern of liver enzyme elevations, and rapid recovery on stopping. Immunoallergic and autoimmune features were not present. The clinical phenotype of injury and associated features have not been reported in any detail. Thus, entacapone may rarely cause clinically apparent liver injury, but it has not been associated with the severe hepatitis and acute liver failure that characterized cases of tolcapone induced liver injury.

Likelihood score: D (possible, rare cause of clinically apparent liver injury).

### Mechanism of Injury

Entacapone is extensively metabolized by the liver and eliminated though biotransformation, mostly by glucuronidation via UDP-glucuronosyl transferase. Polymorphisms of this enzyme have been linked to liver enzyme elevations during therapy, but the relationship between dose, metabolism and liver injury due to entacapone has not been defined.

### Outcome and Management

The cases of hepatotoxicity attributed to entacapone have been mild and self-limiting. There have been no reports of acute liver failure, chronic liver injury or vanishing bile duct syndrome associated with entacapone therapy. In at least one case report, a patient who developed raised serum enzymes during tolcapone therapy, redeveloped enzyme elevations after being switched to entacapone. Otherwise, the liver injury associated with these two COMT inhibitors has been distinct, without evidence of a class effect.

Drug Class: Parkinson Disease Agents

Other Drugs in the Subclass, COMT Inhibitors: Opicapone, Tolcapone

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Entacapone – Generic, Comtan®

DRUG CLASS

Parkinson Disease Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Entacapone)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Entacapone | 130929-57-6 | C14-H15-N3-O5

## ANNOTATED BIBLIOGRAPHY

References updated: 25 October 2021

Abbreviations used: COMT, catechol O-methyltransferase; MAO, monoamine oxidase.

Zimmerman HJ. Antiparkinsonism drugs. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 715-7. (Expert review of hepatotoxicity published in 1999; among anticholinergic agents, "only trihexyphenidyl has been incriminated in hepatic injury"; other antiparkinsonism drugs discussed include levodopa, lergotrile [no longer available], pergolide and bromocriptine, but not entacapone).
Larrey D, Ripault MP. Hepatotoxicity of psychotropic drugs and drugs of abuse. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier Inc, 2013, pp. 443-62. (Review of hepatotoxicity of agents acting on the central nervous system).
Roberson ED. Parkinson Disease. Treatment of central nervous system degenerative disorders. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 328-333. (Textbook of pharmacology and therapeutics).
Waters CH, Kurth M, Bailey P, Shulman LM, LeWitt P, Dorflinger E, Deptula D. (1998). S. Tolcapone in stable Parkinson's disease: efficacy and safety of long-term treatment. Tolcapone Stable Study Group. Neurology. (Among 298 patients with stable Parkinson disease treated with levodopa and either tolcapone [n=196] or placebo [n=102], ALT abnormalities occurred in 3-5% of tolcapone treated patients between month 1 and 6 of therapy, 4 were withdrawn and recovered; abnormalities resolved in another 4 despite continuing on therapy).
Hauser RA, Molho E, Shale H, Pedder S, Dorflinger EE. (1998). A pilot evaluation of the tolerability, safety, and efficacy of tolcapone alone and in combination with oral selegiline in untreated Parkinson's disease patients. Tolcapone De Novo Study Group. Mov Disord. (Among 83 patients with Parkinson disease treated with tolcapone with or without selegiline for 8 weeks, ALT elevations occurred in 1 patient [2%] on tolcapone alone).
Tolcapone for Parkinson's disease. (1998). Med Lett Drugs Ther. (Concise summary of clinical efficacy and safety of tolcapone shortly after its approval in the US; common side effects were diarrhea, increase in levodopa related [dopaminergic] side effects and serum ALT elevations).
Assal F, Spahr L, Hadengue A, Rubbia-Brandt L, Burkhard PR. (1998). Tolcapone and fulminant hepatitis. Lancet. (74 year old woman with Parkinson disease developed jaundice 9 weeks after starting tolcapone [bilirubin 17.1 mg/dL, ALT 2904 U/L, Alk P 177 U/L, protime 21 sec], progressing to hepatic failure and death 2 weeks later).
Rivest J, Barclay CL, Suchowersky O. (1999). COMT inhibitors in Parkinson's disease. Can J Neurol Sci. (Review of efficacy and safety of tolcapone and entacapone in Parkinson disease; ALT elevations above 3 times the ULN occurred in 2-5% of tolcapone, but in no entacapone recipients; reports of 3 cases of acute liver failure due to tolcapone led to its withdrawal in several countries).
Kaakkola S. (2000). Clinical pharmacology, therapeutic use and potential of COMT inhibitors in Parkinson's disease. Drugs. (Review of the mechanism of action, pharmacology, efficacy and side effects of tolcapone and entacapone; both enhance dopaminergic effects of levodopa and diarrhea is a frequent dose modifying side effect; hepatotoxicity occurs with tolcapone, but has not been reported with entacapone).
Lambert D, Waters CH. (2000). Comparative tolerability of the newer generation antiparkinsonian agents. Drugs Aging. (Review of mechanism of action, tolerability and safety of selegiline, pramipexole, ropinirole, tolcapone and entacapone in Parkinson disease).
Olanow CW. (2000). Tolcapone and hepatotoxic effects. Tasmar Advisory Panel. Arch Neurol. (Consensus recommendations for monitoring patients on tolcapone after 4 reports of acute liver failure; among 1535 patients treated in phase III studies, ALT or AST elevations [>3 times ULN] occurred in 1.3-3.7% of patients, returning to normal when discontinued and one woman developed jaundice and died; postmarketing reports included 4 patients, ages 66-74, with onset of symptoms and jaundice after 2-4 months, [bilirubin 6.9-26.1 mg/dL, ALT 1245-5020 U/L, Alk P 66-347 U/L], 3 died within 1-2 weeks of presentation).
Spahr L, Rubbia-Brandt L, Burkhard PR, Assal F, Hadengue A. (2000). Tolcapone-related fulminant hepatitis: electron microscopy shows mitochondrial alterations. Dig Dis Sci. (Histologic analysis of patient with acute liver failure due to tolcapone [Assal 1988], showed multilobular collapse, inflammatory infiltrates including eosinophils, cholestasis, and focal microvesicular steatosis; electron microscopy suggested mitochondrial injury: Case 1).
Watkins P. (2000). COMT inhibitors and liver toxicity. Neurology. (Review of hepatotoxicity of tolcapone and entacapone suggesting that liver injury is not a class effect and that there have been no reports of jaundice attributed to entacapone).
Entacapone for Parkinson's disease. (2000). Med Lett Drugs Ther. (Concise summary of clinical efficacy and safety of entacapone shortly after its approval in the US; common side effects were diarrhea, increase in levodopa related side effects, but no reported hepatotoxicity as occurs with tolcapone).
Blum MW, Siegel AM, Meier R, Hess K. (2001). Neuroleptic malignant-like syndrome and acute hepatitis during tolcapone and clozapine medication. Eur Neurol. (70 year old woman developed stupor, rigidity and hyperthermia with increases in CPK [3132 U/L] and ALT [988 U/L], but not bilirubin or alkaline phosphatase while on the combination of tolcapone and clozapine, resolving rapidly on stopping therapy; compatible with neuroleptic malignant-like syndrome).
Myllylä VV, Kultalahti ER, Haapaniemi H, Leinonen M, FILOMEN Study Group. (2001). Twelve-month safety of entacapone in patients with Parkinson's disease. Eur J Neurol. (Among 326 patients with Parkinson disease treated with entacapone or placebo, ALT elevations occurred in 6.9% on drug vs 4.6% on placebo and were above 3 times ULN in 0.9% vs 0.0%; no patient developed clinically apparent liver injury that could be attributed to entacapone).
Acuña G, Foernzler D, Leong D, Rabbia M, Smit R, Dorflinger E, Gasser R, et al. (2002). Pharmacogenetic analysis of adverse drug effect reveals genetic variant for susceptibility to liver toxicity. Pharmacogenomics J. (DNA genotyping of 30 single nucleotide polymorphisms in 135 patients who had liver enzyme elevations during tolcapone therapy and controls found variants within the UDP-glucuronsyl transferase gene that were associated with liver injury).
Fisher A, Croft-Baker J, Davis M, Purcell P, McLean AJ. (2002). Entacapone-induced hepatotoxicity and hepatic dysfunction. Mov Disord. (Three cases of clinically apparent liver injury attributed to entacapone use; 74 year old woman developed nausea and fatigue 2 weeks after adding entacapone to a regimen of levodopa/benserazide for Parkinson disease [bilirubin 2.4 mg/dL, ALT 104 U/L, Alk P 238 U/L], with rapid improvement on stopping; 2 other cases were reported to Australian Drug Reaction Database with only partial documentation, arising 5 and 6 weeks after starting entacapone, with cholestatic liver enzyme elevations and mild jaundice).
Benabou R, Waters C. (2003). Hepatotoxic profile of catechol-O-methyltransferase inhibitors in Parkinson's disease. Expert Opin Drug Saf. (Review of hepatotoxicity of tolcapone and entacapone).
Borges N. (2003). Tolcapone-related liver dysfunction: implications for use in Parkinson's disease therapy. Drug Saf. (Review of hepatotoxicity of tolcapone and possible mechanisms).
Brooks DJ. (2004). Safety and tolerability of COMT inhibitors. Neurology. (Review of safety and side effects of entacapone; in phase III trials ALT elevations >3 times ULN occurred in 0.3-0.5% of patients taking entacapone and 0.4% on placebo, and there were no cases of jaundice or clinically apparent liver injury among ~1600 entacapone treated patients).
Deane KH, Spieker S, Clarke CE. (2004). Catechol-O-methyltransferase inhibitors for levodopa-induced complications in Parkinson's disease. Cochrane Database Syst Rev. (Systematic review of efficacy of tolcapone and entacapone; ALT elevations reported in variable proportions of patients on tolcapone).
(2005). Levodopa + carbidopa + entacapone. Entacapone: a second look: new preparations. Parkinson's disease: a modest effect. Prescrire Int. (Review of risks and benefits of a fixed dose combination of levodopa, carbidopa and entacapone mentions that entacapone may cause cholestatic hepatitis and that is has not been shown to be more effective than bromocriptine).
Borges N. (2005). Tolcapone in Parkinson's disease: liver toxicity and clinical efficacy. Expert Opin Drug Saf. (Review of hepatotoxicity of tolcapone and its possible mechanisms).
Korri H, Awada A. (2005). Rev Neurol (Paris). (61 year old man with Parkinson disease developed jaundice and fever 17 months after starting tolcapone [bilirubin 3.1 mg/dL, ALT 399 U/L, Alk P 115 U/L], resolving upon stopping).
Martignoni E, Cosentino M, Ferrari M, Porta G, Mattarucchi E, Marino F, Lecchini S, et al. (2005). Two patients with COMT inhibitor-induced hepatic dysfunction and UGT1A9 genetic polymorphism. Neurology. (Two patients who had ALT elevations [78 and 284 U/L] during tolcapone therapy, one of whom had similar elevations during entacapone treatment; both had the A(T)9AT sequence [1A9*1] in the promoter of the UGT1A9 gene).
(2006). Tolcapone: new drug. In Parkinson's disease: unacceptable risk of severe hepatitis. Prescrire Int. (Review of tolcapone as adjunctive therapy in Parkinson disease suggests that the hepatotoxicity risk makes it an unacceptable option).
Leegwater-Kim J, Waters C. (2006). Tolcapone in the management of Parkinson's disease. Expert Opin Pharmacother. (Review on use of tolcapone in Parkinson disease suggesting that with proper monitoring, the potential for hepatotoxicity is "negligibly small").
Stocchi F, De Pandis MF. (2006). Utility of tolcapone in fluctuating Parkinson's disease. Clin Interv Aging. (Review of role of tolcapone in treatment of Parkinson disease, indicating its efficacy in patients with fluctuating symptoms and its safety with proper monitoring of serum enzymes).
Entacapone to Tolcapone Switch Study Investigators. (2007). Entacapone to tolcapone switch: Multicenter double-blind, randomized, active-controlled trial in advanced Parkinson's disease. Mov Disord. (Randomized controlled trial of replacing entacapone with tolcapone in patients with Parkinson disease and motor fluctuations on long term levodopa therapy; ALT elevations occurred in 3% on entacapone and 9% on tolcapone, but were mild and self-limiting).
Leegwater-Kim J, Waters C. (2007). Role of tolcapone in the treatment of Parkinson's disease. Expert Rev Neurother. (Review of the pharmacology, metabolism, clinical efficacy and safety of tolcapone, indicating that the risk of hepatotoxicity "is very small if proper hepatic monitoring guidelines are followed").
Olanow CW, Watkins PB. (2007). Tolcapone: an efficacy and safety review (2007). Clin Neuropharmacol. (Review of the efficacy and safety of tolcapone focusing upon the hepatotoxicity concludes that tolcapone can be used safety if there is strict adherence to routine liver test monitoring requirements of every 2-4 weeks for 6 months and at 3-6 month intervals thereafter).
Lees AJ, Ratziu V, Tolosa E, Oertel WH. (2007). Safety and tolerability of adjunctive tolcapone treatment in patients with early Parkinson's disease. J Neurol Neurosurg Psychiatry. (Controlled trial of tolcapone vs placebo combined with levodopa and carbidopa in 677 patients with early Parkinson disease; ALT or AST elevations occurred in 20% of placebo- vs 27% of tolcapone treated patients and were >3 times ULN in 1.2% [placebo] vs 1.8% [tolcapone], almost all during first 6 months; 1% of tolcapone treated patients stopped because of ALT elevations, but none developed jaundice or clinically apparent liver injury).
Lew MF, Kricorian G. (2007). Results from a 2-year centralized tolcapone liver enzyme monitoring program. Clin Neuropharmacol. (Centralized testing for ALT and AST in 1725 patients with Parkinson disease treated with tolcapone for up to 2 years; 69 [3.9%] had at least one elevation, but <1% had an elevation above 2 times the ULN and most returned to normal despite continuing therapy).
(2008). Entacapone: hepatitis (continued). The risk of liver damage is being confirmed. It is better not to expose parkinsonian patients to this drug. Prescrire Int. (Commentary mentions that the European Medicines Agency has reported 29 cases of hepatic disorders linked to entacapone).
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J, Drug Induced Liver Injury Network (DILIN). (2008). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology. (Among 300 cases of drug induced liver injury in the US collected between 2004 and 2008, none were due to drugs used for Parkinson disease).
Canesi M, Zecchinelli AL, Pezzoli G, Antonini A. (2008). Clinical experience of tolcapone in advanced Parkinson's disease. Neurol Sci. (Among 66 patients with advanced Parkinson disease treated with tolcapone, 2 [3%] were withdrawn from therapy because of ALT elevations).
Brooks DJ, Leinonen M, Kuoppamäki M, Nissinen H. (2008). Five-year efficacy and safety of levodopa/DDCI and entacapone in patients with Parkinson's disease. J Neural Transm. (Retrospective, pooled analysis of 5 controlled trials with 5 year extension phases that included 806 patients with Parkinson disease treated with entacapone added to levodopa/carbodopa; there were "few clinically significant changes in liver function tests" and none of the 478 serious adverse events that were reported were due to hepatotoxicity).
Ebersbach G, Storch A. (2009). Tolcapone in elderly patients with Parkinson's disease: a prospective open-label multicenter non-interventional trial. Arch Gerontol Geriatr. (Among 237 patients with advanced Parkinson disease treated with tolcapone, diarrhea was the most common side effect [3.4%], ALT or AST elevations occurred in 18%, but were mostly mild and "not clinically significant").
McBurney RN, Hines WM, Von Tungeln LS, Schnackenberg LK, Beger RD, Moland CL, Han T, et al. (2009). The liver toxicity biomarker study: phase I design and preliminary results. Toxicol Pathol. (Design and early results of a comprehensive study of rats given 28 days of entacapone or tolcapone as examples of two related agents, one of which causes liver injury in man and one which does not, assessing liver enzymes, histology, gene transcription, proteomics, metabolomics and possible biomarkers to identify predictors of idiosyncratic liver injury in humans).
Reuben A, Koch DG, Lee WM, Acute Liver Failure Study Group. (2010). Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury but none were attributed to agents used for Parkinson disease).
Fischer JJ, Michaelis S, Schrey AK, Graebner OG, Glinski M, Dreger M, Kroll F, et al. (2010). Capture compound mass spectrometry sheds light on the molecular mechanisms of liver toxicity of two Parkinson drugs. Toxicol Sci. (In vitro study of binding of tolcapone and entacapone to other proteins; unlike entacapone, tolcapone interacted with a number of non-COMT intracellular proteins which are involved in the respiratory chain actions, fatty acid beta-oxidation and bile acid synthesis, perhaps accounting for its potential for hepatotoxicity).
Haasio K. (2010). Toxicology and safety of COMT inhibitors. Int Rev Neurobiol. (Extensive review of the mechanism of hepatic injury from tolcapone; "at the moment there is no explanation to the hepatotoxicity appeared in clinical use").
Marsala SZ, Gioulis M, Ceravolo R, Tinazzi M. (2012). A systematic review of catechol-0-methyltransferase inhibitors: efficacy and safety in clinical practice. Clin Neuropharmacol. (Systematic review of literature on safety and efficacy of tolcapone and entacapone recommends use of tolcapone only if entacapone treatment fails and liver tests are normal).
McBurney RN, Hines WM, VonTungeln LS, Schnackenberg LK, Beger RD, Moland CL, Han T, et al. (2012). The liver toxicity biomarker study phase I: markers for the effects of tolcapone or entacapone. Toxicol Pathol. (Comparison of the molecular effects of tolcapone vs entacapone on rat liver and plasma biomarkers found that changes from the two drugs only partially overlapped and different effects were present at 3 and 28 days, suggesting that some of these "off-target" and specific effects of tolcapone may account for its occasional hepatotoxicity).
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. (2013). Incidence, presentation, and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none of the 96 were attributed to an agent used to treat Parkinson disease).
Drugs for Parkinson's disease. (2013). Treat Guidel Med Lett. (Concise review of recommendations for therapy of Parkinson disease with description of mechanisms of action, efficacy and adverse events).
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A, Chirino R, et al. (2014). Profile of idiosyncratic drug induced liver injury in Latin America: an analysis of published reports. Ann Hepatol. (Among 176 reports of drug induced liver injury from Latin America published between 1996 and 2012, none were attributed to an agent to treat Parkinson disease).
Eggert K, Oertel WH, Lees AJ. (2014). German Competence Network on Parkinson’s disease. Safety and efficacy of tolcapone in the long-term use in Parkinson disease: an observational study. Clin Neuropharmacol. (Among 391 patients with Parkinson disease treated with tolcapone in an observation study conducted at 48 neurologic centers and followed for one year, 34 [8.7%] developed liver enzyme elevation, usually within the first 3 months, which were above twice ULN in only 5 [1.3%] and resolved spontaneously in most; no patient developed clinically apparent liver injury).
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al., United States Drug Induced Liver Injury Network. (2015). Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology. (Among 899 cases of drug induced liver injury from the US enrolled in a prospective database between 2004 and 2012, none were attributed to an agent used to treat Parkinson disease).
Longo DM, Yang Y, Watkins PB, Howell BA, Siler SQ. (2016). Elucidating differences in the hepatotoxic potential of tolcapone and entacapone with DILIsym(®), a mechanistic model of drug-induced liver injury. CPT Pharmacometrics Syst Pharmacol. (Description of mechanistic simulation models of the metabolism and toxicity of tolcapone and entacapone which predicted their differential hepatotoxicity).
Lv X, Wang XX, Hou J, Fang ZZ, Wu JJ, Cao YF, Liu SW, et al. (2016). Comparison of the inhibitory effects of tolcapone and entacapone against human UDP-glucuronosyl-transferases. Toxicol Appl Pharmacol. (Comparison of the inhibitory effects of tolcapone and entacapone against recombinant human UGTs showed more potent inhibition by tolcapone for most isoforms).
Drugs for Parkinson's disease. (2017). Med Lett Drugs Ther. (Concise review of medications approved for use in Parkinson disease including levodopa/carbidopa, dopamine agonists, MAO-B inhibitors, anticholinergics, and COMT inhibitors, mentions hepatotoxicity of tolcapone but not of levodopa or any of the other adjunctive therapies: “Use of tolcapone requires written informed consent and monitoring of liver function every 2-4 weeks for the first 6 months of treatment and periodically thereafter. Serious hepatoxicity has not been reported with entacapone”).
Margolesky J, Singer C. (2017). Extended-release oral capsule of carbidopa-levodopa in Parkinson disease. Ther Adv Neurol Disord. (Review of the pharmacology, efficacy and safety of extended release carbidopa/levodopa in listing of reported adverse reactions; there is no mention of serious hepatic events or ALT elevations).
Mak A, Kato R, Weston K, Hayes A, Uetrecht J. (2018). Editor's highlight: An impaired immune tolerance animal model distinguishes the potential of troglitazone/pioglitazone and tolcapone/entacapone to cause IDILI. Toxicol Sci. (In an animal model of idiosyncratic liver injury using PD-1 knock out mice treated with anti-CTLA-4 to decrease the natural inhibition of T cell responses [immune check point], treatment with tolcapone caused greater injury than treatment with entacapone, while neither agent caused liver injury in wild type mice or PD-1 knock out mice without anti-CTLA-4 treatment, suggesting that idiosyncratic liver injury is immune mediated, caused by an unregulated CD-8+ response and failure of immune tolerance).
Fremont R, Manoochehri M, Armstrong NM, Mattay VS, Apud JA, Tierney MC, Devanand DP, et al. (2020). Tolcapone treatment for cognitive and behavioral symptoms in behavioral variant frontotemporal dementia: a placebo-controlled crossover study. J Alzheimers Dis. (Among 28 adults with frontotemporal dementia with behavioral symptoms who were treated with tolcapone [200 mg] or placebo three times daily for 9 days in a cross-over design, tolcapone therapy was associated with slight improvements in some cognitive and behavioral scores and was well tolerated, although 21% of patients developed mild liver enzyme elevations [less than twice ULN] that were asymptomatic and resolved rapidly).
Artusi CA, Sarro L, Imbalzano G, Fabbri M, Lopiano L. (2021). Safety and efficacy of tolcapone in Parkinson's disease: systematic review. Eur J Clin Pharmacol. (Systematic review of the literature on the efficacy and safety of tolcapone identified 32 studies with 4780 patients, of whom 0.9% developed liver enzyme elevations above 2 times ULN; and, while there were 3 case reports of fatal acute liver failure all reported in 1998, since then there have been no deaths and only 3 non-fatal cases).
Drugs for Parkinson's disease. (2021). Med Lett Drugs Ther. (Concise review of current medications approved for use in Parkinson disease including levodopa/carbidopa, dopamine agonists, COMT inhibitors, MAO-B inhibitors, anticholinergics, and istradefylline, mentions hepatotoxicity of tolcapone but not of levodopa or any of the adjunctive therapies).
Hauser RA, Hattori N, Fernandez H, Isaacson SH, Mochizuki H, Rascol O, Stocchi F, et al. (2021). Efficacy of istradefylline, an adenosine A2A receptor antagonist, as adjunctive therapy to levodopa in Parkinson's disease: a pooled analysis of 8 phase 2b/3 trials. J Parkinsons Dis. (In a pooled analysis of 8 randomized placebo-controlled trials of istradefylline in 2719 patients with Parkinson disease and motor complications, while adverse event rates were similar in the 3 groups [71% and 70% vs 65%] except for dyskinesia [16% and 18% vs 10%], and “no clinically meaningful changes in laboratory parameters…were observed” in any group including those on levodopa/carbidopa alone).

## OTHER REFERENCE LINKS

1 Recent References on Entacapone: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Entacapone/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Entacapone: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Entacapone)